# Hydrocodone

## OVERVIEW

### Introduction

Hydrocodone is a semisynthetic, moderately potent, orally available opioid that, in combination with acetaminophen, is widely used for treatment of acute or chronic pain, and in combination with antihistamines or anticholinergics used to treat cough. Hydrocodone by itself has not been linked to serum enzyme elevations during therapy or to clinically apparent liver injury, but the combination with acetaminophen has been linked to many cases of acute liver failure due to unintentional overdose with acetaminophen.

### Background

Hydrocodone (hye” droe koe’ done) is a semisynthetic derivative of codeine or thebaine, natural alkaloids derived from the resin of poppy seeds (Papaver somniferum). It is well absorbed orally and has moderate opiate activity (approximately 6 times that of codeine), acting an agonist of the µ opiate receptor. The combination of hydrocodone with acetaminophen is effective in ameliorating moderate-to-moderately severe pain and is widely used for temporary as well as chronic management of pain states. The combination of hydrocodone with acetaminophen or other products helps to prevent its recreational use and administration by injection. Hydrocodone has been in use since shortly after its initial synthesis in the 1920’s, but was formally approved for use in combination with acetaminophen in the United States in 1998. Current indications are for treatment of moderate-to-moderately severe pain (combinations with acetaminophen or ibuprofen) or alleviation of cough and symptoms of upper respiratory tract infections (combined with chlorpheniramine or homatropine). It is currently one of the most commonly prescribed drugs in medical practice. Hydrocodone is available in multiple formulations (tablets, capsules, syrup) combined with other analgesics, antihistamines or anticholinergics in concentrations of 2.5, 5, 7.5 and 10 mg generically and (with acetaminophen) under brand names such as Vicodin, Norco, Lortab and Co-Gesic, among others. The preparations are generally taken every 4 to 6 hours. Importantly, the dose of acetaminophen in hydrocodone combinations varies from 300 to 1000 mg per tablet. The FDA, however, has recommended that physicians not use opioid combinations with concentrations of acetaminophen of more than 325 mg per unit dose. Side effects of hydrocodone include sedation, respiratory depression, mental clouding, euphoria, agitation, constipation, diarrhea, abdominal bloating, nausea, vomiting, headache and dizziness. Severe adverse events include life-threatening respiratory depression, addiction, abuse, opioid withdrawal, serotonin syndrome (when used with serotonergic agents) and adrenal insufficiency. Hydrocodone is a controlled substances and classified as a Schedule III drug, indicating that it has medical usefulness, but also a potential for physical and psychological dependency and abuse.

### Hepatotoxicity

Despite wide scale use for many decades, hydrocodone by itself has not been convincingly linked to instances of clinically apparent acute liver injury. However, when combined with acetaminophen, hydrocodone combinations have become a common cause of acetaminophen acute liver injury. The typical history is of a patient who began taking more than the prescribed number of pills over several days, attempting to achieve more of an opiate effect and leading secondarily and unintentionally to an overdose of acetaminophen. Because of their potential for hepatotoxicity, opioid combinations in which the dose of acetaminophen is greater than 325 mg per tablet or capsule were discontinued.

Hydrocodone, like other opiates, is metabolized in the liver by the P450 microsomal oxidizing enzyme system, and levels can be significantly affected by either inhibitors of CYP 3A4 (which increase levels and can lead to toxicity) or inducers of the enzyme (which decrease levels and can affect efficacy).

Likelihood score: E (unlikely cause of clinically apparent liver injury).

References on the safety and potential hepatotoxicity of hydrocodone are given in the Overview section of the Opioids.

Drug Class: Opioids

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Hydrocodone (with Acetaminophen) – Generic, Co-Gesic®, Vicodin®

DRUG CLASS

Opioids

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Hydrocodone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Hydrocodone | 125-29-1 | C18-H21-N-O3

## OTHER REFERENCE LINKS

1 Recent References on Hydrocodone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Hydrocodone+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Hydrocodone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Hydrocodone)